# Bacopa monnieri

## OVERVIEW

### Introduction

Bacopa is an herbal extract made from the leaves of Bacopa monnieri, a herbaceous plant native to the Indian subcontinent which has been used in Ayurvedic medicine for centuries to treat anxiety, insomnia, and epilepsy and to improve memory and cognitive function. Bacopa has not been linked to liver enzyme elevations during therapy nor to instances of clinically apparent acute liver injury.

### Background

Bacopa is an herbal extract made from the fresh or dried leaves of Bacopa monnieri, a creeping, herbaceous plant native to the Indian subcontinent that has been used for centuries in Ayurvedic medicine to treat anxiety, depression, memory loss, and epilepsy. Currently it is widely used to boost memory and improve cognitive function and mental focus. Also known as water hyssop, bacopa monnieri leaves and roots have more than 100 components including flavonoids, flavones, saponins, triterpenoids, glycosides, sterols, and lipids. The active ingredients are thought to be saponin glycosides referred to as bacosides. In vitro and in vivo studies suggest that bacosides have anxiolytic, antiinflammatory, antioxidant, antiulcer, and neuroprotective properties leading to purported effects in many diseases and disease conditions including dementia, hyperactivity, memory loss, and depression. However, bacopa has not been shown to be effective for any disease or medical symptom in adequately controlled, prospective trials in humans, and bacopa is not approved in the United States as therapy of any medical condition. Nevertheless, Bacopa monnieri is available in multiple over-the-counter herbal products. The typical dose is 300 to 600 mg of the extract daily, the equivalent of 5 to 10 grams of the dried herb. Bacopa has only minor and usually short-lived side effects which may include abdominal pain, nausea, diarrhea, flatulence, dry mouth, headache, dizziness, insomnia, and rash. The overall rate of adverse events in bacopa-treated subjects has usually been similar to that in placebo controls. In small clinical trials, bacopa has had no serious or severe adverse effects.

### Hepatotoxicity

Bacopa extract has not been linked to serum enzyme elevations during therapy, although there have been few prospective studies in humans that have reported on laboratory test results during treatment. Importantly, despite widespread use, bacopa has not been implicated in cases of clinically apparent liver disease.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of liver injury

There is no evidence to indicate that Bacopa monnieri causes liver injury despite the fact that it has multiple ingredients including triterpenoid bacopa saponins and saponin glycosides.

Other Names: Brahmi (a name also used for Gotu kola), Andri, Water Hyssop, Indian Pennywort

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bacopa – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bacoside | 11028-00-5 | C41-H68-O13
Bacoside A1 | 58798-94-0 (https://pubchem.ncbi.nlm.nih.gov/compound/Bacoside-A1) | C40-H64-O12 | At PubChem [CAS RN Link]
Bacoside A2 | 58798-95-1 (https://pubchem.ncbi.nlm.nih.gov/compound/85067758) | C46-H74-O17 | At PubChem; [CAS RN Link]
Bacoside A3 | 157408-08-7 | C47-H76-O18
Bacoside B | 11048-52-5 | C41-H68-O

## ANNOTATED BIBLIOGRAPHY

References updated: 24 April 2024

Abbreviation: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but bacopa is not mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbals does not mention bacopa).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were specifically attributed to a product containing bacopa). 15390328
Pravina K, Ravindra KR, Goudar KS, Vinod DR, Joshua AJ, Wasim P, Venkateshwarlu K, et al. Safety evaluation of BacoMind in healthy volunteers: a phase I study. Phytomedicine. 2007;14:301-8. (Among 23 healthy volunteers treated with a preparation of Bacopa monnieri [300 mg for 15 days and 450 mg for 15 days], there were no serious adverse events, and while minor nonspecific adverse events occurred, there were no changes in clinical laboratory tests). 17442556
Calabrese C, Gregory WL, Leo M, Kraemer D, Bone K, Oken B. Effects of a standardized Bacopa monnieri extract on cognitive performance, anxiety, and depression in the elderly: a randomized, double-blind, placebo-controlled trial. J Altern Complement Med. 2008;14:707-13. (Among 54 elderly volunteers without symptoms of dementia who were treated with oral bacopa [300 mg] or placebo daily for 12 weeks, standardized tests for delayed recall and reaction times improved slightly with bacopa and did not change with placebo; while total adverse events rates were similar in the two groups and there were no serious adverse events, and ALT elevations or hepatotoxicity were not mentioned). 18611150
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by "natural remedies": an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to bacopa). 19159172
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling, and the frequent underreporting of herbal use by patients. Regulation of HDS is under DSHEA, which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs and includes HDS; HDS induced liver injury is a growing problem and currently accounts for at least 10% of cases of acute liver injury due to medications). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no mention of bacopa). 19650152
Teschke R, Bahre R. Severe hepatotoxicity by Indian Ayurvedic herbal products: a structured causality assessment. Ann Hepatol. 2009;8:258-66 (64 year old woman with treatment resistant vitiligo developed jaundice 7 months after starting a regimen of Ayurvedic medications including Bakuchi, Khadin, Brahmi [possibly Bacopa monnieri], and usher [bilirubin 5.0 mg/dL, ALT 601 U/L, Alk P 306 U/L, ANA 1:320], which resolved with stopping all four but causality assessment pointed to Bakuchi [Psoralea corylifolia] as the cause). 19841509
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to bacopa). 20949552
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, lists bacopa as an Ayurvedic herbal product). 22928722
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a product containing bacopa). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea, and none were attributed to bacopa [see also Navarro et al Hepatology 2014]). 25754159
Haslan H, Suhaimi FH, Das S. Herbal supplements and hepatotoxicity: a short review. Nat Prod Commun. 2015;10:1779-84. (Review of liver injury due to herbal supplements does not mention bacopa). 26669124
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: 537. (Listing of published cases of liver injury from HDS products does not mention or list bacopa). 27070596
Kean JD, Downey LA, Stough C. A systematic review of the Ayurvedic medicinal herb Bacopa monnieri in child and adolescent populations. Complement Ther Med. 2016;29:56-62. (Systematic review of the literature on the effects Bacopa monnieri on memory and cognition in children and adolescents identified five studies which consistently demonstrated improvements in language behavior and memory by bacopa therapy with lesser effects on hyperactivity and concentration, and with a low rate [2.5%] of adverse events which were generally mild and short-lived; no mention of ALT elevations or hepatotoxicity). 27912958
Kean JD, Downey LA, Stough C. Systematic overview of Bacopa monnieri (L.) Wettst. dominant poly-herbal formulas in children and adolescents. Medicines (Basel). 2017;4:86. (Systematic review of randomized clinical trials on the cognitive and behavioral effects of Bacopa monnieri in children and adolescents identified 9 studies, all of which showed effects on some cognitive or language function and most of which reported no or few adverse events and no serious adverse events or mention of ALT elevations or hepatotoxicity). 29165401
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107: 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not mention bacopa) . 27402097
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. Liver injury from herbal and dietary supplements. Hepatology 2017; 65: 363-73. (Review of the problems of liver injury and HDS products, mentions that multiingredient dietary supplements account for the major of cases but does not mention a product with bacopa as a component). 27677775
Mitra-Ganguli T, Kalita S, Bhushan S, Stough C, Kean J, Wang N, Sethi V, Khadilkar A. A randomized, double-blind study assessing changes in cognitive function in Indian school children receiving a combination of Bacopa monnieri and micronutrient supplementation vs. placebo. Front Pharmacol. 2017;8:678. (Among 300 Indian school children, ages 7 to 12 years, treated with Bacopa monnieri fortified with micronutrients or an non-fortified isocaloric control for 4 months, there were no differences in changes of cognitive function or short term memory, and adverse event rates were similar in the two groups with no serious adverse events; no mention of ALT elevations or hepatotoxicity). 29204115
Cicero AFG, Fogacci F, Banach M. Botanicals and phytochemicals active on cognitive decline: The clinical evidence. Pharmacol Res. 2018;130:204-212. (Review of the literature on botanicals efficacy and safety in treating cognitive decline discusses potential mechanisms of action of Bacopa monnieri and mentions that “extracts were overall well-tolerated”; no mention of ALT elevations or hepatotoxicity). 29289576
Santos G, Gasca J, Parana R, Nunes V, Schinnoni M, Medina-Caliz I, Cabello MR, Lucena MI, et al. Profile of herbal and dietary supplements induced liver injury in Latin America: A systematic review of published reports. Phytother Res. 2021;35:6-19. (Review of reports of liver injury due to herbal supplements reported from Latin America does not mention cases due to bacopa). 32525269
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; bacopa is not mentioned). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5], and garcinia [n=3]; bacopa is not mentioned). 33434654
Basheer A, Agarwal A, Mishra B, Gupta A, Padma Srivastava MV, Kirubakaran R, Vishnu V. Use of Bacopa monnieri in the treatment of dementia due to Alzheimer disease: systematic review of randomized controlled trials. Interact J Med Res. 2022;11:e38542. (Systematic review of clinical trials of bacopa in Alzheimer disease identified 5 studies all of which reported a statistically significant effect of the herb, but all of which had limitations, but “no major safety issues were reported”, and there was no mention of ALT elevations or hepatotoxicity). 35612544
Kean JD, Downey LA, Sarris J, Kaufman J, Zangara A, Stough C. Effects of Bacopa monnieri (CDRI 08®) in a population of males exhibiting inattention and hyperactivity aged 6 to 14 years: a randomized, double-blind, placebo-controlled trial. Phytother Res. 2022;36:996-1012. (Among 93 male children, ages 6 to 14, with inattention or hyperactivity treated with Bacopa monnieri or placebo for 14 weeks, there were minor differences in various measures of cognitive function and mood, but no differences in behavioral outcomes and no serious adverse events, 3 children receiving the herbal preparation complained of short-lived gastrointestinal discomfort; no mention of ALT elevations or hepatotoxicity). 35041248
Cave AE, Chang DH, Münch GW, Steiner-Lim GZ. A systematic review of the safety and efficacy on cognitive function of herbal and nutritional medicines in older adults with and without subjective cognitive impairment. Syst Rev. 2023;12:143. (Review of efficacy and safety of herbal products purported to improve cognitive function identified 21 clinical trials in 1891 older adults, 14 of which showed some improvement in cognitive function with the intervention including several using Bacopa monnieri). 37592293

## OTHER REFERENCE LINKS

Recent References on Bacopa monnieri: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bacopa+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Bacopa monnieri: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bacopa)